# Elotuzumab

## OVERVIEW

### Introduction

Elotuzumab is a humanized monoclonal antibody to cell surface receptor SLAMF7 which is used in combination with other antineoplastic agents in the therapy of multiple myeloma. Elotuzumab has been implicated in rare instances of transient, marked serum enzyme elevations, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Elotuzumab (el" oh tooz' ue mab) is humanized IgG1 monoclonal antibody to the cell surface receptor signaling lymphocyte activation molecule family member 7 (SLAMF7), which is a transmembrane glycoprotein that is frequently overexpressed on multiple myeloma cells and is found normally on natural killer (NK) cells. The monoclonal antibody binds to the cell surface receptor and triggers cell apoptosis of cancer cells and activation of NK cells which may increase its antineoplastic activity. In preregistration trials, the addition of elotuzumab to lenalidomide and dexamethasone led to an increase in overall response rates and prolongation of progression-free survival. Elotuzumab was given accelerated approval for use in the United States in 2015. Current indications are as therapy of refractory multiple myeloma administered in combination with lenalidomide (or bortezomib) and dexamethasone or as monotherapy in patients who have failed at least three previous regimens. Elotuzumab is available as a powder for reconstitution in single use vials of 300 or 400 mg under the brand name Empliciti. The recommended dose is 10 mg/kg intravenously every week for 2 cycles and every 2 weeks thereafter until disease progression or unacceptable toxicities occur. Premedication with dexamethasone, diphenhydramine, ranitidine and acetaminophen is recommended. Side effects are common and can include infusion reactions, fatigue, diarrhea, constipation, anorexia, fever, cough, nasopharyngitis, peripheral neuropathy and pneumonia. Uncommon, but potentially severe adverse reactions include severe infusion reactions, bacterial infections and secondary malignancies.

### Hepatotoxicity

In preregistration trials of elotuzumab for multiple myeloma, serum enzyme elevations were frequent, but were similar in patients receiving lenalidomide and dexamethasone with elotuzumab as in those on lenalidomide and dexamethasone alone, any ALT elevation occurring in 55% vs 51% and ALT elevations above 5 times the upper limit of normal in 4.4% vs 4.1%. The Food and Drug Administration analysis of submitted results described one case of suspected injury due to elotuzumab with jaundice and serum ALT elevations and a liver biopsy demonstrating possible drug induced liver injury. On the basis of this report, the product label for elotuzumab warned of possible rare instances of hepatotoxicity. Since approval and more wide scale use of elotuzumab, there have been no further published reports of its hepatotoxicity.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury during elotuzumab therapy is not known and separation of the possible role of elotuzumab versus lenalidomide or other antineoplastic agents given concurrently is difficult. Nevertheless, the monoclonal antibody may cause liver injury through its indirect effects on inhibition of SLAMF7 signaling in the liver or activation of NK cells.

### Outcome and Management

The liver injury attributed to elotuzumab has usually been self-limited and not associated with symptoms or jaundice. Patients who develop persistent serum enzyme elevations above 5 times the upper limit of normal should have therapy withheld until values decline. Patients who develop symptoms of liver injury or jaundice with serum enzyme elevations should have therapy discontinued. There is no information on possible cross sensitivity to the injury among different monoclonal antibodies.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## CASE REPORT

### Case 1. Acute liver injury arising during elotuzumab, lenalidomide and dexamethasone therapy of multiple myeloma.

[Modified from: FDA analysis]

A 54 year old man with relapsed multiple myeloma, previously treated with bortezomib, melphalan and dexamethasone followed by autologous hemopoietic stem cell transplant, developed jaundice approximately 7 months after enrolling in an experimental trial of elotuzumab combined with lenalidomide and dexamethasone. He had a previous history of nonalcoholic fatty liver disease and pretreatment laboratory tests demonstrated elevations in ALT (134 U/L) and AST (101 U/L), with normal alkaline phosphatase and bilirubin levels (Table). Further elevations in aminotransferases occurred 6 months into therapy which worsened and were associated with jaundice a few weeks later. All therapy was stopped and he underwent evaluation which showed no evidence of infection with hepatitis A, B, C or E, while abdominal imaging showed fatty liver without changes suggestive of biliary obstruction. Serum bilirubin levels rose to 8.1 mg/dL and a liver biopsy showed changes of chronic hepatitis with cirrhosis and decrease in bile ducts. After several weeks, laboratory test results began to improve and returned to close to baseline levels by 6 weeks after onset.

#### Key Points

Medication: | Elotuzumab with lenalidomide and dexamethasone
Pattern: | Hepatocellular (R=7.6)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 30 weeks
Recovery: | 6 weeks
Other medications: | Metformin, oxycodone, penicillin, valaciclovir, leucovorin, levothyroxine, sulfamethoxazole, trimethoprim, sertraline, perindopril, lormetazepam, repaglinide, insulin, aspirin, quinine, fenofibrate and omeprazole

#### Key Points

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Elotuzumab, Lenalidomide and Dexamethasone
0 | Pre | 134 | 94 | 0.8 | Started chemotherapy
28 | Pre | 82 | 95 | 0.8 | Started 2nd cycle
196 | Pre | 90 | 146 | 0.9
210 | 0 | 527 | 173 | 2.0
216 | 15 | 713 | | 8.1.
234 | 33 | 77 | 184 | 2.8
253 | 52 | 46 | 151 | 1.8 | Liver biopsy
Normal Values | | <50 | <120 | <1.2

#### Comment

These results were analyzed by FDA staff during the review of results from a phase III study of lenalidomide and dexamethasone (a standard second line therapy of multiple myeloma) with or without elotuzumab. Some degree of serum enzyme elevations was common, occurring in more than half of patients, but this individual developed the combination of jaundice with ALT elevations that were above 5 times ULN with only minor elevations in alkaline phosphatase, a pattern referred to as "Hy's Law", in reference to Hyman J. Zimmerman who noted that the mortality rate of drug induced liver injury is above 10% if jaundice arises with a hepatocellular pattern of serum enzymes. While this case appears to be drug induced liver injury, one cannot say for sure that it was due to elotuzumab as opposed to lenalidomide (a well known cause) or one of the many other medications that he was taking. Complicating the case was the presence of evidence of nonalcoholic fatty liver disease even before the chemotherapy was started, so that the case is an example of acute injury superimposed upon chronic liver disease (acute-on-chronic). The prompt discontinuation of therapy was likely important in insuring a beneficial outcome. A liver biopsy done somewhat late in the course of the injury showed cirrhosis, chronic hepatitis and a decrease in bile ducts, a finding that would not be expected from hepatocellular injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elotuzumab – Empliciti®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Elotuzumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elotuzumab | 915296-00-3 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs; mentions that "biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Lonial S, Dimopoulos M, Palumbo A, White D, Grosicki S, Spicka I, Walter-Croneck A, et al.; ELOQUENT-2 Investigators. Elotuzumab therapy for relapsed or refractory multiple myeloma. N Engl J Med 2015; 373: 621-31. (Among 646 patients with refractory multiple myeloma treated with lenalidomide and dexamethasone with or without elotuzumab for an average of 2 years, progression-free survival was prolonged by addition of elotuzumab [median 19 vs 15 months], and side effects were common but similar between the two groups, except for infusion reactions [10% vs none]; no mention of ALT elevations or hepatotoxicity). 26035255
Mateos MV, Granell M, Oriol A, Martinez-Lopez J, Blade J, Hernandez MT, Martín J, et al. Elotuzumab in combination with thalidomide and low-dose dexamethasone: a phase 2 single-arm safety study in patients with relapsed/refractory multiple myeloma. Br J Haematol 2016; 175: 448-56. (Among 40 patients with refractory multiple myeloma treated with elotuzumab combined with thalidomide and dexamethasone, the overall response rate was 38% and adverse events were frequent, including fatigue and edema, but there were no liver related serious adverse events or deaths and no mention of ALT elevations). 27434748
Richardson PG, Jagannath S, Moreau P, Jakubowiak AJ, Raab MS, Facon T, Vij R, et al.; 1703 study investigators. Elotuzumab in combination with lenalidomide and dexamethasone in patients with relapsed multiple myeloma: final phase 2 results from the randomised, open-label, phase 1b-2 dose-escalation study. Lancet Haematol 2015; 2: e516-27. (Among 73 patients with relapsed multiple myeloma after 1 to 3 previous treatments who were treated with elotuzumab [10 or 20 mg/kg weekly for 8 weeks and then every other week], 61 [84%] achieved an objective response, and adverse events included diarrhea [66%], muscle spasms [62%], fatigue [56%] and bone marrow suppression, but there were no liver related severe adverse events or deaths and no mention of ALT elevations). 26686406
Markham A. Elotuzumab: first global approval. Drugs 2016; 76: 397-403. (Review of the mechanism of action, clinical efficacy and safety of elotuzumab after its approval for use in refractory multiple myeloma; does not mention ALT elevations or hepatotoxicity). 26809244
Three new drugs for multiple myeloma. Med Lett Drugs Ther 2016; 58 (1495): e70-1. (Concise review of three agents that had been recently approved for use in multiple myeloma including elotuzumab; no mention of ALT elevations or hepatotoxicity). 27192621
Gormley NJ, Ko CW, Deisseroth A, Nie L, Kaminskas E, Kormanik N, Goldberg KB, et al. FDA drug approval: elotuzumab in combination with lenalidomide and dexamethasone for the treatment of relapsed or refractory multiple myeloma. Clin Cancer Res 2017; 23 (22): 6759-63. (Summary of the data on safety and efficacy of elotuzumab that provided the basis for its approval; mentions that severe adverse reactions include infusion reactions, infections, secondary malignancies and hepatotoxicity). 28249893
Brioli A, Mügge LO, Hochhaus A, Von Lilienfeld-Toal M. Safety issues and management of toxicities associated with new treatments for multiple myeloma. Expert Rev Hematol 2017; 10: 193-205. (Review of adverse events from new treatments of multiple myeloma and their management; does not specifically discuss hepatotoxicity). 28116920
Kapoor P, Rajkumar SV. Multiple myeloma in 2016: Fresh perspectives on treatment and moments of clarity. Nat Rev Clin Oncol 2017; 14: 73-4. (Review of new agents for therapy of multiple myeloma, focusing upon the advantages of triple therapy). 28071678
Center for Drug Evaluation and Research. Elotuzumab. Medical/Statistical Review(s). https://www.accessdata.fda.gov/drugsatfda_docs/nda/2015/761035Orig1s000MedR.pdf (accessed: March 31, 2017).

## OTHER REFERENCE LINKS

1. Recent References on Elotuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Elotuzumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Elotuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Elotuzumab)